# Eravacycline

## OVERVIEW

### Introduction

Eravacycline is a parenterally administered tetracycline-like antibiotic used to treat moderate-to-severe intraabdominal infections due to susceptible organisms. Eravacycline use has been associated with a low rate of serum enzyme elevations during therapy but has not been convincingly linked to instances of clinically apparent acute liver injury.

### Background

Eravacycline (er" a va sye' kleen) is an intravenously administered fluorocycline antibiotic in the tetracycline class with broad spectrum activity against many gram-positive and gram-negative, aerobic and anaerobic organisms including multidrug resistant organisms. Eravacycline is similar to tigecycline both in structure and in spectrum of activity and may have somewhat greater potency in vitro. Tetracycline antibiotics act by binding to bacterial ribosomes and inhibiting protein synthesis. In clinical trials, intravenous eravacycline was found to be effective in treating intraabdominal infections. Eravacycline was approved for use in the United States in 2018 for complicated intraabdominal infections in adults and is available as 50 and 100 mg of lyophilized powder in single dose vials for reconstitution under the brand name Xerava. The recommended dose is 1 mg per kilogram intravenously every 12 hours for total of 4 to 14 days. An oral formulation for continuation as outpatient therapy was investigated during development but was discontinued because of suboptimal efficacy. Common side effects of eravacycline include gastrointestinal upset, nausea and vomiting, and infusion site reactions. Tetracyclines can cause vertigo and tinnitus, skin photosensitivity reactions, hypersensitivity reactions, Clostridioides difficile associated diarrhea, and staining of developing teeth and inhibition of bone growth in children or when taken by a pregnant mother, for which reasons eravacycline should not be used in pregnant women or children below the age of nine.

### Hepatotoxicity

In pre-registration clinical trials of intravenous eravacycline, serum aminotransferase elevations occurred in 9% to 20% of patients, but were transient, mild to moderate in severity, and no more frequent than with placebo or comparator treatment arms. In some patients in these clinical trials, elevations in serum ALT or AST led to early discontinuations of therapy, but the abnormalities resolved often without either dose modification or stopping. There were no instances of clinically apparent liver injury with symptoms or jaundice that were attributed to eravacycline. Thus, mild liver test abnormalities are common during eravacycline therapy but may be due to the underlying disease or bacterial infection or other medications such as antibiotics that are used in combination.

Nevertheless, other tetracycline antibiotics are well known causes of drug induced liver injury. In particular, high doses of intravenous tetracycline are known to be able to cause severe hepatic microvesicular steatosis with lactic acidosis and severe hepatic dysfunction (LASH syndrome). For this reason, intravenous tetracycline was withdrawn from use. This complication has not been reported with intravenous eravacycline but rare instances similar in clinical features have been reported with tigecycline. The oral tetracyclines have also been linked to idiosyncratic liver injury with autoimmune features that generally arise with long term use and has most commonly been associated with minocycline. This complication also has not been reported with eravacycline, omadacycline or tigecycline which are usually given in short courses only.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which eravacycline might cause liver injury is unknown. Eravacycline is metabolized in the liver by the microsomal cytochrome P450 system, largely via CYP 3A4, and liver injury might be caused by a toxic or immunogenic intermediate. Eravacycline is susceptible to drug-drug interactions with modulators of CYP 3A4, inducers causing a decrease in eravacycline plasma levels.

### Outcome and Management

Patients on intravenous eravacycline who develop serum aminotransferase elevations that rise above 5 times the upper limit of normal or are accompanied by jaundice or symptoms should have eravacycline discontinued. Whether there is cross sensitivity to hepatic injury among the various tetracyclines is not known, but switching to another class of antibiotics would be more appropriate than changing to another tetracycline-like agent in patients who develop significant hepatic injury while receiving eravacycline.

Drug Class: Antiinfective Agents, Tetracyclines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eravacycline – Xerava®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eravacycline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Eravacycline | 1207283-85-9 | C27-H31-N4-O8

## ANNOTATED BIBLIOGRAPHY

References updated: 15 June 2026

Abbreviations used: ULN, upper limit of normal; iv, intravenous; ANA, antinuclear antibody.
Zimmerman HJ. Tetracyclines. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 599-602. (Expert review of tetracycline and liver injury published in 1999, long before the availability of eravacycline; the tetracyclines cause two forms of drug induced liver injury, microvesicular fat and liver failure occurring after 4-10 days with high doses of parenteral tetracyclines and an idiosyncratic liver injury that occurs with the oral agents, doxycycline typically causing a cholestatic and minocycline a hepatocellular injury which may be associated with autoimmune features).
Moseley RH. Tetracyclines. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 468. (Expert review of tetracycline induced liver injury; mentions that the hepatotoxicity of intravenous tetracycline is of historic interest only as it is no longer given parenterally; both doxycycline and minocycline have been associated with idiosyncratic liver injury; tigecycline and eravacycline are not discussed).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that the toxicity profile of eravacycline is consistent with other tetracycline-like antibiotics, and while ALT elevations above twice ULN arose in 9-20% of eravacycline treated subjects, these rates were no different than with comparator antibiotics–such as meropenem and ertapenem [10-19%] and no patient developed clinically apparent liver injury attributable to eravacycline).
Solomkin JS, Ramesh MK, Cesnauskas G, Novikovs N, Stefanova P, Sutcliffe JA, Walpole SM, et al. Phase 2, randomized, double-blind study of the efficacy and safety of two dose regimens of eravacycline versus ertapenem for adult community-acquired complicated intra-abdominal infections. Antimicrob Agents Chemother 2014; 58: 1847-54. (Among 139 patients with intraabdominal infections treated with eravacycline [1.0 mg/kg every 12 hours or 1.5 mg/kg every 24 hours] vs ertapenem [1 g every 24 hours], clinical success rates were similar [100% and 93% vs 92%] and no “safety signals as evaluated by laboratory tests… were identified”). 24342651
Zhanel GG, Cheung D, Adam H, Zelenitsky S, Golden A, Schweizer F, Gorityala B, et al. Review of eravacycline, a novel fluorocycline antibacterial agent. Drugs 2016; 76: 567-88. (Review of the structure, antibacterial spectrum of activity, pharmacology, clinical efficacy and safety of eravacycline; mentions that the most common adverse event is nausea and vomiting, but that other event rates are similar to those in comparator arm subjects; no discussion of ALT elevations or hepatotoxicity). 26863149
Solomkin J, Evans D, Slepavicius A, Lee P, Marsh A, Tsai L, Sutcliffe JA, et al. Assessing the efficacy and safety of eravacycline vs ertapenem in complicated intra-abdominal infections in the investigating gram-negative infections treated with eravacycline (IGNITE 1) trial: a randomized clinical trial. JAMA Surg 2017; 152: 224-32. (Among 541 patients with complicated intraabdominal infections treated with eravacycline [1 mg/kg every 12 hours] or ertapenem [1 gm every 24 hours] for 4-14 days, rates of clinical cure were similar [87% vs 88%] while adverse events were more frequent with eravacycline [42% vs 28%], although severe adverse event rates were similar [6% vs 5.6%]; no mention of ALT elevations or hepatotoxicity). 27851857
Newman JV, Zhou J, Izmailyan S, Tsai L. Randomized, double-blind, placebo-controlled studies of the safety and pharmacokinetics of single and multiple ascending doses of eravacycline. Antimicrob Agents Chemother 2018; 62. pii: e01174-18. (Pharmacokinetic studies in healthy subjects indicated that a 1 mg/kg dose of eravacycline was most appropriate and that it was generally well tolerated with dose related nausea, infusion site reactions, and superficial phlebitis being the most common adverse events). 30150464
Solomkin JS, Gardovskis J, Lawrence K, Montravers P, Sway A, Evans D, Tsai L. IGNITE4: Results of a phase 3, randomized, multicenter, prospective trial of eravacycline vs. meropenem in the treatment of complicated intra-abdominal infections. Clin Infect Dis 2018 Dec 18. [Epub ahead of print] PMID: (Among 400 hospitalized patients with intraabdominal infections treated with eravacycline or meropenem intravenously for 4-14 days, clinical cure rates were similar [91% vs 91%], and adverse events included nausea [5%], vomiting [4%], and diarrhea [3%]; no mention of ALT elevations or hepatotoxicity). 30561562
Eravacycline (Xerava)--an IV tetracycline for complicated intra-abdominal infections. Med Lett Drugs Ther. 2019;61(1570):61-63. (Concise review of the mechanism of action, pharmacology, clinical efficacy, safety, and costs of eravacycline shortly after its approval in the United States, mentions common adverse events of infusion site reactions, nausea, and vomiting, and warns of possible photosensitivity and hypersensitivity reactions, inhibition of bone growth, discoloration of tooth enamel, and pseudotumor cerebri; no mention of ALT elevations or hepatotoxicity). 31169809
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. [] (Analysis of tetracyclines in the FDA’s Adverse Event Reporting System [FAERS] over a 16 year period, identified 1435 cases of liver injury, the most being associated with minocycline [n=547], doxycycline [545], tigecycline [288], and tetracycline [41] with few to omadacycline [4], oxytetracycline [3], eravacycline [2], sarecycline [2], and demeclocycline [1]; no clinical details provided). 35364753
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of idiosyncratic drug induced liver injury enrolled in a prospective Latin American database, 4 [0.9%] were attributed to minocycline, 1 [0.2%] each to doxycycline and tetracycline but none to eravacycline, omadacycline, sarecycline, or tigecycline). 38992407
McCourt NM, Krsak M, Brade K, Casias M. Real-world safety and efficacy data comparing dosing strategies of eravacycline: a retrospective cohort study. Hosp Pharm. 2026:00185787261417158. (Among 133 patients, ages 18 to 89 years, treated with intravenous eravacycline in doses of 1.5 mg/kg once daily vs 1.0 mg/kg twice daily at a single U.S. University hospital, success rates were similar 54% vs 46% with once vs twice daily dosing, and liver test abnormalities arose in 13% vs 6.5%, but no clinical details provided and no mention of clinically apparent liver injury). 41675142
Kunz Coyne AJ, Alosaimy S, Lucas K, Lagnf AM, Morrisette T, Molina KC, DeKerlegand A, et al. Eravacycline, the first four years: health outcomes and tolerability data for 19 hospitals in 5 U.S. regions from 2018 to 2022. Microbiol Spectr. 2024;12:e0235123. (Among 416 patients who were treated with eravacycline for at least 3 days at 19 U.S. medical centers, therapy was successful in 76% of cases, 9% of patients had an adverse event which were mostly mild-to-moderate gastrointestinal complaints, and 7 [1.7%] patients had liver injury which resulted in early drug discontinuation in 3 [no details or definitions provided]). 38018984
Koomanan N, Zhou YP, Kwa ALH. The efficacy and safety of eravacycline in the management of infections: a single-center experience. Antibiotics (Basel). 2026;15:474. (Among 140 adult patients who received 2 days or more of eravacycline therapy in a single Singapore hospital for a median of 14 days, the success rate was 70% and adverse event rate 52%, including “hepatotoxicity” in 33 [22%] leading to discontinuation in 9 [no clinical details provided]). 42192696
Hou Y, Zhang L, Li H, Zhong L, Zhang H, Tang T, Zheng X, et al. Efficacy, safety, and population pharmacokinetics of eravacycline for carbapenem-resistant organism infections in immunocompromised hosts: A multicenter prospective cohort study. Int J Antimicrob Agents. 2026;67:107795. (Among 177 immunocompromised patients with a serious carbapenem resistant infection treated with eravacycline for at least 72 hours, treatment related adverse events arose in 24 [14%] but most were mild to moderate not requiring discontinuation, and no “hepatorenal toxicities” occurred). 41921670

## OTHER REFERENCE LINKS

1. Recent References on Eravacycline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(eravacycline/AE+AND+tigecycline%5BNM%5D)+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver+OR+liver+diseases/CI)+AND+(%222008/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Eravacycline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=eravacycline)